# Tamoxifen

## OVERVIEW

### Introduction

Tamoxifen is a nonsteroidal antiestrogen that is widely used in the treatment and prevention of breast cancer. Long term tamoxifen therapy has been associated with development of fatty liver, steatohepatitis, cirrhosis, and rare instances of clinically apparent acute liver injury.

### Background

Tamoxifen (ta mox' i fen) is referred to as a selective estrogen receptor modulator with tissue specific actions, having estrogenic agonist effects on bone, brain and liver, but antagonist activity on breast tissue. Tamoxifen may also have other, as yet undefined, anticancer effects. Adjuvant therapy with tamoxifen has been shown to prolong survival in women with early stage breast cancer and to decrease the risk of de novo breast cancer as well as recurrence in women at high risk. Tamoxifen was approved for use in the United States in 1977 and is still widely used, being considered a first line adjuvant therapy for breast cancer. Current indications include both treatment of breast cancer and reduction of breast cancer risk in women at high risk. Tamoxifen is available in 10 and 20 mg tablets generically and under several trade names such as Nolvadex and Tamone. Tamoxifen is also available as an oral solution (10 mg/5 mL). The usual dose for treating breast cancer is 20 to 40 mg daily, and for secondary prevention is 20 mg once daily for five years. Common side effects include hot flashes, nausea, diarrhea, amenorrhea, altered menses, weight change and fluid retention. Rare but potentially severe adverse events include stroke, pulmonary embolus and venous thromboses, uterine cancer and other malignancies.

### Hepatotoxicity

Tamoxifen has been associated with rare instances of idiosyncratic, clinically apparent liver injury, typically arising within the first six months of treatment and having variable presentations with cholestatic, mixed or hepatocellular pattern of enzyme elevations. Immunoallergic features (fever, rash, eosinophilia) are uncommon, as are autoantibodies. Some instances have been severe with signs of hepatic failure, but most cases are self-limited.

More commonly, long term tamoxifen therapy has been linked to the development of fatty liver and steatohepatitis. In some prospective studies, up to one third of women have developed fatty liver during 1 to 3 years of tamoxifen therapy, as shown by routine imaging using computerized tomography. Fatty liver usually becomes demonstrable within 1 to 2 years of starting tamoxifen but is usually not accompanied by symptoms, although serum aminotransferase levels may be elevated modestly in up to half of patients. Liver biopsy may demonstrate steatohepatitis and a proportion of women develop hepatic fibrosis. Several instances of cirrhosis have been described after therapy with tamoxifen for 3 to 5 years. Serum aminotransferase elevations and fatty liver generally improve once tamoxifen is stopped, but the improvement may be slow and in rare instances, signs and symptoms of portal hypertension persist. While the frequency of hepatic steatosis during tamoxifen therapy is higher in women with higher body weight and body mass index (BMI), the appearance of fatty liver is usually not accompanied by change in body weight and does not relate to alcohol use or receipt of adjuvant chemotherapy. Because steatohepatitis is usually (although not always) accompanied by minor serum aminotransferase elevations, monitoring of serum enzymes during long term tamoxifen therapy is often recommended.

In addition, long term tamoxifen therapy has also been linked to isolated cases of peliosis hepatis, hepatic cysts and several cases of hepatocellular carcinoma in women with no other risk factors for this tumor. However, in large retrospective analyses, no increase in hepatocellular carcinoma in women taking tamoxifen for 5 years has been demonstrated, although these same studies did show an increase in rates of endometrial carcinoma. Tamoxifen also been linked to an increased risk of venous thromboses, and instances of portal vein thrombosis with combinations of portal hypertension and esophageal variceal bleeding have been reported.

Finally, tamoxifen use has been associated with development of symptomatic porphyria cutanea tarda (PCT), presenting after 1 to 4 years of use with skin fragility, hypertrichosis and reddish urine and accompanied by elevations in urinary porphyrins and mild serum aminotransferase elevations. Tamoxifen related cases usually arise without other risk factors for PCT such as iron overload, alcohol abuse or hepatitis C virus infection. Stopping tamoxifen is followed by gradual improvement in symptoms, decrease in porphyrin excretion and improvement in liver enzymes.

Likelihood score: B (highly likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The acute form of liver injury attributed to tamoxifen use is probably due to an idiosyncratic reaction to a metabolite of the medication rather than its estrogenic effects. In contrast, the induction of fatty liver and triggering of porphyria cutanea tarda are likely due to estrogenic effects on the liver in the setting of a genetic predisposition to fatty liver disease or porphyria cutanea tarda.

### Outcome and Management

While fatty liver arises in at least one third of women treated with tamoxifen for up to 5 years, clinically significant steatohepatitis is less common. Nevertheless, monitoring of serum aminotransferase levels during tamoxifen therapy is appropriate. In women with persistent elevations in ALT levels, the relative benefits and risks of continuing tamoxifen therapy must be weighed. Factors to help in the decision, include noninvasive tests for hepatic fibrosis (platelet count), imaging of the liver and, in some instances, liver biopsy. Switching to aromatase inhibitors such as anastrozole, letrozole or exemestane is another option. These agents may also cause or exacerbate fatty liver disease, but the risk appears far less than with tamoxifen. Other approaches short of stopping tamoxifen therapy include nutritional advice and weight loss, abstinence from alcohol, and possibly medical therapies for nonalcoholic steatohepatitis (which are currently investigational and have not been shown to be specifically helpful in tamoxifen induced fatty liver). The possible development of serious hepatic fibrosis and portal hypertension can be assessed noninvasively by serial determinations of platelet count, but may require liver biopsy to document.

Drug Class: Antineoplastic Agents, Antiestrogens

## CASE REPORTS

### Case 1. Clinically apparent, acute liver injury due to tamoxifen.(1)

A 75 year old woman developed nausea, vomiting and mild serum enzyme elevations 10 weeks after starting tamoxifen (10 mg twice daily) for metastatic breast cancer. She was treated with prednisolone (5 mg daily) and antiemetics, but continued to be symptomatic and serum enzymes and bilirubin continued to rise (Table). She had no history of liver disease, denied alcohol use and had no risk factors for viral hepatitis. Tests for hepatitis A and B were negative. Ultrasound of the abdomen showed no gallstones or evidence of biliary obstruction. A liver biopsy showed cholestasis and portal inflammation with minimal bile duct changes. All medications were stopped except for prednisolone, and liver test abnormalities began to decrease towards near normal levels. Tamoxifen was restarted for 12 days and she was monitored closely. Within 9 days she became symptomatic with nausea and vomiting and serum enzyme levels began to rise, peaking a few days after tamoxifen was stopped and then returning again towards normal. Shortly thereafter, she died of cerebral metastases. On autopsy, she had small hepatic metastases, but no evidence of biliary obstruction.

#### Key Points

Medication: | Tamoxifen (20 mg daily)
Pattern: | Mixed (alkaline phosphatase levels were raised, but no values given)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 10 weeks
Recovery: | 2-3 weeks
Other medications: | Prednisolone, antiemetics

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Bilirubin (mg/dL) | Other
0 | | 38 | 0.7 | Tamoxifen started
4 weeks | | 35 | 0.9
10 weeks | | 54 | 0.9 | Symptoms (nausea)
14 weeks | 0 | 735 | 4.1 | Worsening symptoms
15 weeks | 1 week | 670 | 5.3
16 weeks | 2 weeks | 110 | 3.5
19 weeks | 5 weeks | 54 | 1.0 | Nausea resolved
21 weeks | 7 weeks | 50 | 1.4
Time After restarting | Time After Stopping | Tamoxifen restarted
1 week | 0 | 79 | 1.1 | Symptoms (nausea)
2 weeks | 1 week | 258 | 1.8
3 weeks | 2 weeks | 180 | 1.3
5 weeks | 4 weeks | 64 | 1.2
Normal Values | | <45 | <1.2

* Values estimated from Figure.

#### Comment

The clinical presentation of symptomatic liver injury 10 weeks after starting tamoxifen and recurrence of a similar pattern of injury within 2 weeks of restarting provides strong evidence for the role of tamoxifen in causing the liver injury. Cases of acute liver injury with jaundice due to tamoxifen have been reported, but are rare and represent an idiosyncratic reaction. More common is fatty liver disease which can be associated with significant steatohepatitis and result in cirrhosis. However, steatosis and steatohepatitis rarely cause jaundice and are usually minimally symptomatic and respond slowly to withdrawal of tamoxifen. Furthermore, in this patient, ultrasonography and ultimately autopsy did not demonstrate significant steatosis. While tests for hepatitis C and E were not available to exclude those diagnoses, the reappearance of injury on rechallenge makes it likely that tamoxifen was the primary cause of symptoms and liver test abnormalities.

### Case 2. Nonalcoholic steatohepatitis induced by tamoxifen therapy.(2)

A 37 year old woman was found to have abnormal serum enzymes during long term tamoxifen therapy. Two years previously, she had been found to have bilateral breast cancers and underwent bilateral mastectomies followed by reconstructive breast surgery. The breast cancer tissue was human estrogen receptor negative. She was started on long term tamoxifen (20 mg daily) and goserelin (3.6 mg implant monthly) therapy. Before starting therapy, her serum enzymes were normal (Table), but one year later they were found to be elevated. She had no symptoms of liver disease and specifically denied fatigue, nausea and abdominal pain. She had no history of liver disease and denied alcohol use. She had no risk factors for viral hepatitis and was not taking other medications. Physical examination showed no fever, rash, abdominal tenderness or enlargement of liver or spleen. She was mildly overweight (body mass index 28.5), but had not gained weight in the previous year. Laboratory results showed moderate elevations in serum aminotransferase levels (ALT 150 U/L, AST 138 U/L) with normal alkaline phosphatase, bilirubin (0.3 mg/dL), albumin (4.5 g/dL) and prothrombin time (INR 1.1). Fasting blood glucose and lipids were normal. Tests for hepatitis A, B and C were negative as were autoantibodies. Serum ceruloplasmin was normal (34.4 mg/dL). Ultrasound of the abdomen suggested fatty liver. A liver biopsy showed severe macrovesicular steatosis with lobular hepatitis, and mild pericellular fibrosis without Mallory bodies, compatible with steatohepatitis. The combination of ursodeoxycholic acid, vitamin C and vitamin E were started and tamoxifen continued. Serum enzymes remained elevated and six months later began to rise reaching a peak of an ALT 770 U/L, AST 810 U/L, despite minimal or no rise in alkaline phosphatase and bilirubin levels. At this point, the patient began to complain of fatigue, nausea, vague abdominal discomfort, dark urine and itching. Tamoxifen and goserelin were discontinued. A repeat liver biopsy showed less steatosis, but increased lobular inflammation, ballooning degeneration and fibrosis with multiple Mallory bodies. Over the next several months, serum aminotransferases decreased minimally.

#### Key Points

Medication: | Tamoxifen (20 mg daily)
Pattern: | Hepatocellular (R=15)
Severity: | 1+ (serum enzyme elevations only with symptoms)
Latency: | 2 years
Recovery: | Incomplete after 2 months
Other medications: | Goserelin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 24 | 55 | 0.7 | 1 month before surgery
18 months | | 150 | 65 | 0.2
20 months | | 189 | 75 | 0.3 | Liver biopsy
21 months | | 143 | 67 | 0.3 | Vitamin E and ursodiol
23 months | | 149 | 65 | 0.3
26 months | | 292 | 64 | 0.4
29 months | 0 | 770 | 112 | 0.5 | Tamoxifen stopped
30 months | 1 month | 567 | 103 | 0.5 | Liver biopsy
31 months | 2 months | 418 | 102 | 0.4
Normal Values | | <40 | <104 | <1.2

#### Comment

Fatty liver develops in up to one third of women treated with tamoxifen, but is usually benign and not associated with serum enzyme elevations, symptoms or progressive liver disease. In a proportion of patients, however, the accumulation of fat is associated with appearance of inflammation and cell injury (steatohepatitis) which can lead to progressive fibrosis and ultimately to cirrhosis. Serum aminotransferase levels are usually minimally elevated. In this case, ALT elevations were dramatic and persistent, leading to liver biopsy and attempts to treat the fatty liver injury using ursodiol and vitamin E while continuing tamoxifen. These interventions appeared to have no effect, and serum enzymes continued to rise. A follow up liver biopsy showed worsening of the injury and progressive fibrosis. Stopping tamoxifen led to improvements in serum enzyme elevations, but the improvement was slow and incomplete at the time she was last seen.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tamoxifen – Generic, Nolvadex®, Tamone®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tamoxifen)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tamoxifen | 10540-29-1 | C26-H29-N-O

## CITED REFERENCES

1 Blackburn AM, Amiel SA, Millis RR, Rubens RD. (1984). Tamoxifen and liver damage. Br Med J (Clin Res Ed).
2 Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology.

## ANNOTATED BIBLIOGRAPHY

References updated: 20 August 2020

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 699. (Expert review of hepatotoxicity published in 1999, mentions that tamoxifen can lead to cholestasis, peliosis, fatty liver, and steatohepatitis).
Chitturi S, Farrell GC. Estrogen receptor antagonists. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of tamoxifen mentions that nonalcoholic fatty liver disease is the most common form of liver injury due to tamoxifen which has also been reported to cause peliosis hepatis, acute hepatitis, submassive hepatic necrosis and liver cancer).
Isaacs C, Wellstein A, Riegel AT. Hormones and related agents in the therapy of cancer. In, Brunton LL, Hilal-Dandan, R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1237-47. (Textbook of pharmacology and therapeutics).
Ward HW. (1973). Anti-oestrogen therapy for breast cancer: a trial of tamoxifen at two dose levels. Br Med J. (68 women with advanced breast cancer received either 10 or 20 mg of tamoxifen daily; response rates were 60-77%, 4 patients had ALT elevations, but also had metastases; "There was no evidence that the drug had any effect on liver function").
Patterson JS, Baum M. (1978). Safety of tamoxifen. Lancet. (Among 988 patients treated in 12 studies, only 2.7% were withdrawn for suspected toxicity which was mostly gastrointestinal; no mention of hepatotoxicity).
Agrawal BL, Zelkowitz L. (1981). Bone flare: hypercalcemia and jaundice after tamoxifen therapy. Arch Intern Med. (59 year old woman with bone metastases from breast cancer developed hypercalcemia and jaundice [peak bilirubin 13.5 mg/dL, AST 46 U/L, Alk P 411 U/L] 2 weeks after starting tamoxifen, resolving upon stopping and recurring 4 days after starting diethylstilbestrol).
Shah KA, Levin J, Rosen N, Greenwald E, Zumoff B. (1982). Allopurinol hepatotoxicity potentiated by tamoxifen. N Y State J Med. (69 year old man with prostate cancer on allopurinol for 12 years developed fever, leukocytosis and alkaline phosphatase elevations within 24 hours of starting tamoxifen, all of which resolved within 3 days of stopping allopurinol).
Nand S, Gordon LI, Brestan E, Harris C, Brandt T. (1982). Benign hepatic cyst in a patient on antiestrogen therapy for metastatic breast cancer. Cancer. (74 year old woman with metastatic breast cancer on tamoxifen for 14 months developed abdominal pain due to a large benign hepatic cyst, requiring aspiration for decompression).
Loomus GN, Aneja P, Bota RA. (1983). A case of peliosis hepatis in association with tamoxifen therapy. Am J Clin Pathol. (58 year old woman on tamoxifen for 4 years after breast cancer surgery developed sudden hepatic rupture and autopsy showed peliosis hepatis).
Blackburn AM, Amiel SA, Millis RR, Rubens RD. (1984). Tamoxifen and liver damage. Br Med J (Clin Res Ed). (75 year old woman developed nausea and jaundice 10 weeks after starting tamoxifen for metastatic breast cancer [bilirubin 5.3 mg/dL, AST 730 U/L], resolving rapidly upon stopping and recurring within 9 days [bilirubin 2.0 mg/dL, AST 280 U/L], this case being only 1 of 873 treated patients with hepatotoxicity: Case 1).
Fisher B, Redmond C, Legault-Poisson S, Dimitrov NV, Brown AM, Wickerham DL, Wolmark N, et al. (1990). Postoperative chemotherapy and tamoxifen compared with tamoxifen alone in the treatment of positive-node breast cancer patients aged 50 years and older with tumors responsive to tamoxifen: results from the National Surgical Adjuvant Breast and Bowel Project B-16. J Clin Oncol. (Controlled trial in 1124 women with breast cancer treated with tamoxifen alone or in combination with chemotherapy showed benefit of chemotherapy on disease free survival; no mention of hepatotoxicity).
Ching CK, Smith PG, Long RG. (1992). Tamoxifen-associated hepatocellular damage and agranulocytosis. Lancet. (58 year old woman developed nausea and jaundice 5 months after starting tamoxifen for breast cancer [bilirubin 14.3 mg/dL, ALT 1155 U/L], with progressive worsening and death 7 weeks later, autopsy showing massive necrosis).
(1992). Systemic treatment of early breast cancer by hormonal, cytotoxic, or immune therapy. 133 randomised trials involving 31,000 recurrences and 24,000 deaths among 75,000 women. Early Breast Cancer Trialists' Collaborative Group. Lancet. (Combined results of outcome of tamoxifen therapy in 75,000 women showed reductions in rates of recurrence and death and decrease in cancer in contralateral breast for first 4 years of therapy).
Plowman PN. (1993). Tamoxifen as adjuvant therapy in breast cancer. Drugs. (Review of the history, mechanism of action, clinical efficacy and toxicity of tamoxifen; common side effects are vasomotor symptoms, vaginal discharge, and endometrial hyperplasia, rare serious side effects include endometrial carcinoma, ocular toxicity and increased thromboses; hepatotoxicity not discussed).
Maruyama S, Hirayama C, Abe J, Tanaka J, Matsui K. (1995). Chronic active hepatitis and liver cirrhosis in association with combined tamoxifen/tegafur adjuvant therapy. Dig Dis Sci. (Two women, ages 38 and 41 with breast cancer, developed fatigue and jaundice 3 to 8 months after starting tamoxifen and tegafur, an antimetabolite similar to 5-fluorouracil [bilirubin 3.0 and 15.4 mg/dL, ALT 239 and 144 U/L, Alk P 169 and 151 U/L], resolving within 2-3 months of stopping, biopsies showing chronic hepatitis in one and cirrhosis in other).
Pratt DS, Knox TA, Erban J. (1995). Tamoxifen-induced steatohepatitis. Ann Intern Med. (55 year old woman found to have elevations in ALT [164 U/L] 2 years after starting tamoxifen, liver biopsy showing steatohepatitis, ALT becoming normal 4 months after stopping).
Cortez-Pinto H, Baptista A, Camilo ME, de Costa EB, Valente A, de Moura MC. (1995). Tamoxifen-associated steatohepatitis - report of three cases. J Hepatol. (3 cases of steatohepatitis in overweight-obese, nondiabetic women taking tamoxifen for breast cancer with ALT elevations [58, 86 and 119 U/L] found 5-6 months after starting tamoxifen, biopsies showing fat, ballooning degeneration, Mallory bodies and sinusoidal fibrosis; ALT fell to normal 2-5 months after stopping).
Van Hoof M, Rahier J, Horsmans Y. (1996). Tamoxifen-induced steatohepatitis. Ann Intern Med. (72 year old woman developed mild ALT elevations [~1.5 times ULN] 7 months after starting tamoxifen which persisted and after 2 years she had thrombocytopenia, varices, and steatohepatitis with cirrhosis on liver biopsy).
Wilking N, Isaksson E, von Schoultz E. (1997). Tamoxifen and secondary tumours. An update. Drug Saf. (There have been anecdotal reports of hepatocellular carcinoma in women taking tamoxifen, but no increase was found in large prospective studies or various population based studies).
Floren LC, Hebert MF, Venook AP, Jordan VC, Cisneros A, Somberg KA. (1998). Tamoxifen in liver disease: potential exacerbation of hepatic dysfunction. Ann Oncol. (48 year old woman with cirrhosis due to hepatitis B developed jaundice [bilirubin rising from 8.3 to 19.9 mg/dL] 7 days after starting tamoxifen, resolving slowly upon lowering dose to 10 mg every other day).
Fisher B, Constantino JP, Wickerham DL, Redmond CK, Kavanah M, Cronin WM, Vogel V, et al. (1998). Tamoxifen for prevention of breast cancer: report of the National Surgical Adjuvant Breast and Bowel Project P-1 Study. J Natl Cancer Inst. (Among 13,388 women at increased risk for breast cancer treated with tamoxifen or placebo for 5 years, tamoxifen reduced risk of cancer by 49% [22 vs 43.4/1000]; hepatotoxicity not mentioned, but there were no cases of liver cancer or deaths from liver disease in either group).
Vilches AR, Pérez V, Suchecki DE. (1998). Raloxifene-associated hepatitis. Lancet. (49 year old woman developed fatigue and jaundice followed by itching one month after starting raloxifene [bilirubin 6.2 mg/dL, ALT 291 U/L, Alk P 643 U/L], with mild rash and eosinophilia, slow resolution upon stopping).
Ogawa Y, Murata Y, Nishioka A, Inomata T, Yoshida S. (1998). Tamoxifen-induced fatty liver in patients with breast cancer. Lancet. (Fatty liver found by computed tomography in 24 of 66 [36%] patients with breast cancer treated with tamoxifen).
Malina L. (1999). Michalívá, Hussarová. Cas Lek Cesk. (Abstract only; case report of woman taking tamoxifen and other antineoplastic agents who developed porphyria cutanea tarda).
Oien KA, Moffat D, Curry GW, Dickson J, Habeshaw T, Mills PR, McSween RN. (1999). Cirrhosis with steatohepatitis after adjuvant tamoxifen. Lancet. (Two women with breast cancer developed abnormal liver tests 1.5-2 years after starting tamoxifen [AST 45 and 105 U/L, Alk P 303 and 287 U/L, BMI 25 and 32 kg/m2], with follow up liver biopsies showing cirrhosis and steatohepatitis).
Saibara T, Onishi S, Ogawa Y, Yoshida S, Enzan H. (1999). Bezafibrate for tamoxifen-induced non-alcoholic steatohepatitis. Lancet. (Two patients with fatty liver on tamoxifen therapy had decrease in fat content after adding bezafibrate therapy to tamoxifen).
Saibara T, Onishi S, Ogawa Y, Yoshida S, Enzan H. (1999). Non-alcoholic steatohepatitis. Lancet. (Letter discussing role of tamoxifen in causing nonalcoholic steatohepatitis).
Law CH, Tandan VR. (1999). The association between tamoxifen and the development of hepatocellular carcinoma: case report and literature review. Can J Surg. (56 year old woman developed hepatocellular carcinoma an unspecified time after a 6 year course of tamoxifen for breast cancer having no other risk factors and normal nontumorous liver histology).
Dray X, Tainturier MH, De La Lande P, Marty O, Mallet L. (2000). Gastroenterol Clin Biol. (65 year old woman with breast cancer developed abnormal liver tests 3 years after starting tamoxifen [ALT and Alk P 1.5 times ULN], with fatty liver by ultrasound; resolving upon stopping, but having cirrhosis diagnosed during follow up).
Hamada N, Ogawa Y, Saibara T, Murata Y, Kariya S, Nishioka A, Terashima M, et al. (2000). Toremifene-induced fatty liver and NASH in breast cancer patients with breast-conservation treatment. Int J Oncol. (Among 52 women with breast cancer treated with toremifene for 3 to 5 years, 4 [8%] developed fatty liver by CT, 2 with raised ALT and AST and one with steatohepatitis on liver biopsy).
Storen EC, Hay JE, Kaur J, Zahasky K, Hartmann L. (2000). Tamoxifen-induced submassive hepatic necrosis. Cancer J. (59 year old woman with breast cancer developed jaundice 4-5 months after starting tamoxifen [bilirubin 26.6 mg/dL, ALT 1277 U/L], with slow but ultimate recovery over next 4 months after stopping).
Murata Y, Ogawa Y, Saibara T, Nishioka A, Fujiwara Y, Fukumoto M, Inomata T, et al. (2000). Unrecognized hepatic steatosis and non-alcoholic steatohepatitis in adjuvant tamoxifen for breast cancer patients. Oncol Rep. (Among 105 women with breast cancer receiving tamoxifen, 40 [38%] developed fatty liver by CT despite no change in body weight [usually within 2 years; half had raised ALT levels] compared to none of 31 controls followed with annual CT scans; sustained ALT elevations [59-141 U/L] occurred only in those with fatty liver and correlated with moderate to severe steatosis and inflammation on biopsy).
Cai Q, Bensen M, Greene R, Kirchner J. (2000). Tamoxifen-induced transient multifocal hepatic fatty infiltration. Am J Gastroenterol. (69 year old woman taking tamoxifen for many years was found to have asymptomatic but persistent elevations in serum enzymes [ALT 32-56 U/L, AST 71-109 U/L with normal bilirubin and Alk P], imaging showing focal fatty change in the liver and biopsy showing steatohepatitis; enzyme elevations and hepatic fat decreased upon stopping tamoxifen).
Moffat DF, Oien KA, Dickson J, Habeshaw T, McLellan DR. (2000). Hepatocellular carcinoma after long-term tamoxifen therapy. Ann Oncol. (71 year old woman with breast cancer developed abdominal pain and hepatocellular carcinoma after 12 years of tamoxifen therapy [AST 145 U/L, Alk P 378 U/L, alpha fetoprotein 320 ng/dL]; no mention of weight or hepatitis serology).
Kotiloglu G, Aki ZS, Ozyilkan O, Kutlay L. (2001). Tamoxifen-induced cirrhotic process. Breast J. (50 year old woman with breast cancer developed persistent elevations in serum ALT [70-118 U/L] starting 6 months after starting tamoxifen with liver biopsy showing severe steatohepatitis and fibrosis; patient was obese; no mention of symptoms or other liver tests).
Nguyen MC, Stewart RB, Banerji MA, Gordon DH, Kral JG. (2001). Relationships between tamoxifen use, liver fat and body fat distribution in women with breast cancer. Int J Obes Relat Metab Disord. (Cross sectional study of 32 women taking tamoxifen and 39 convenience controls showing decreased liver density and greater visceral fat by computerized tomography in those on tamoxifen).
Nemoto Y, Saibara T, Ogawa Y, Zhang T, Xu N, Ono M, Akisawa N, et al. (2002). Tamoxifen-induced nonalcoholic steatohepatitis in breast cancer patients treated with adjuvant tamoxifen. Intern Med. (Among 56 Japanese women with breast cancer, 19 [34%] developed fatty liver within 2 years as shown by annual CT scans, those with severe steatosis were treated with bezafibrate with improvements in liver fat and serum enzyme elevations).
Coskun U, Töruner FB, Günel N. (2002). Tamoxifen therapy and hepatic steatosis. Neoplasma. (Among 52 women with breast cancer treated with tamoxifen for 6 months, 22 [42%] developed fatty liver shown by ultrasound, but without significant changes in serum lipids and no overall increase in serum enzymes).
Farrell GC. (2002). Drugs and steatohepatitis. Semin Liver Dis. (Review of drug induced steatohepatitis; tamoxifen has been associated with fatty liver, steatohepatitis and cirrhosis usually arising after 1-2 years of therapy and improving upon stopping treatment; pathogenesis is unknown but may be related to alterations in lipid metabolism).
Lasso De La Vega MC, Zapater P, Such J, Sola-Vera J, Payá A, Horga JF, Pérez-Mateo M. (2002). Gastroenterol Hepatol. (56 year old woman with breast cancer developed liver test abnormalities and periodic attacks of abdominal pain 2-3 years after starting tamoxifen [bilirubin 1.2-2.4 mg/dL, ALT 184-104 U/L, Alk P 1-2 times ULN], with biopsy showing chronic hepatitis and steatosis; tamoxifen was continued on advice of her gynecologist and enzymes remained elevated).
Agarwal R, Peters TJ, Coombes RC, Vigushin DM. (2002). Tamoxifen-related porphyria cutanea tarda. Med Oncol. (58 year old woman developed porphyria cutanea tarda after four years of tamoxifen therapy for breast cancer [bilirubin 0.5 mg/dL, ALT 48 U/L, Alk P 84 U/L] with no iron overload, hepatitis C or alcohol abuse, symptoms and liver tests improving on stopping tamoxifen).
Kanda T, Yokosuka O, Chiba T, Kojima H, Fukai K, Imazeki F, Saisho H. (2002). Nippon Shokakibyo Gakkai Zasshi.
Günel N, Coskun U, Toruner FB, Sancak B, Yilmaz E, Cengiz O, Elbeg S, et al. (2003). Serum leptin levels are associated with tamoxifen-induced hepatic steatosis. Curr Med Res Opin. (Among 34 women, 15 [44%] developed hepatic steatosis as detected by ultrasonography 3 months after starting tamoxifen for breast cancer; body weight and cholesterol did not change, but leptin levels rose in those developing steatosis but not in those without).
Nishino M, Hayakawa K, Nakamura Y, Morimoto T, Mukaihara S. (2003). Effects of tamoxifen on hepatic fat content and the development of hepatic steatosis in patients with breast cancer: high frequency of involvement and rapid reversal after completion of tamoxifen therapy. Am J Roentgenol. (Among 67 women with breast cancer treated with tamoxifen followed with annual CT scans of the liver, 43% developed steatosis, all within 2 years, which was severe in 6% and which improved to baseline after therapy; no patient developed cirrhosis).
Murata Y, Ogawa Y, Saibara T, Nishioka A, Takeuchi N, Kariya S, Onishi S, et al. (2003). Tamoxifen-induced non-alcoholic steatohepatitis in patients with breast cancer: determination of a suitable biopsy site for diagnosis. Oncol Rep. (Among 38 Japanese women with breast cancer treated with tamoxifen, CT scans of the liver showed increased fat in 13 [34%], which was often patchy and greater in the right than left lobe).
Ogawa Y, Murata Y, Saibara T, Nishioka A, Kariya S, Yoshida S. (2003). Follow-up CT findings of tamoxifen-induced non-alcoholic steatohepatitis (NASH) of breast cancer patients treated with bezafibrate. Oncol Report. (Among 333 Japanese women with breast cancer treated with tamoxifen, CT scans of the liver showed marked fat in 15 who then underwent liver biopsy which showed steatohepatitis in 14; adding bezafibrate allowed for continuation of tamoxifen, and improvements in liver fat were demonstrated in 5 of 6 patients).
Elefsiniotis IS, Pantazis KD, Ilias A, Pallis L, Mariolis A, Glynou I, Kada H, et al. (2004). Tamoxifen induced hepatotoxicity in breast cancer patients with pre-existing liver steatosis: the role of glucose intolerance. Eur J Gastroenterol Hepatol. (Among 60 women with breast cancer receiving tamoxifen who had hepatic steatosis before starting tamoxifen, serum ALT levels rose in 26 [43%], and more commonly in those with higher BMI, glucose, cholesterol and triglyceride levels at baseline; ALT levels fell to normal within 6 months in all 18 patients who stopped tamoxifen).
Bruno S, Maisonneuve P, Castellana P, Rotmensz N, Rossi S, Maggioni M, Persico M, et al. (2005). Incidence and risk factors for non-alcoholic steatohepatitis: prospective study of 5408 women enrolled in Italian tamoxifen chemoprevention trial. BMJ. (Among 5408 Italian women with breast cancer treated with tamoxifen or placebo for 5 years, 64 developed persistent de novo elevations in serum ALT which was attributable to fatty liver in 52 [control 0.7% vs tamoxifen 1.3%]; hazard ratio [HR] for fatty liver was 2.0 for tamoxifen, but association was limited to overweight [HR 3.2] or obese [HR 5.4] women and none developed signs of cirrhosis).
Nagaie T, Hashimoto M, Kai M, Yamashiata N, Kondo J, Tokunaga M, Miyazaki M, et al. (2005). Changes in hepatic parenchymal ultrasound images in tamoxifen medication patients. Gan To Kagaku Ryoho. (Abstract only; among 156 women with breast cancer treated with tamoxifen, 36% developed ultrasound changes indicative of fatty liver, most within 6-12 months of starting).
Ohnishi T, Ogawa Y, Saibara T, Nishioka A, Kariya S, Fukumoto M, Onishi S, et al. (2005). CYP17 polymorphism and tamoxifen-induced hepatic steatosis. Hepatol Res. (Among 180 women treated with tamoxifen for breast cancer, 57 [32%] developed hepatic steatosis as shown by CT; risk was higher [odds ratio=1.9] in those with CYP17 polymorphisms associated with higher serum estrogen levels).
Grieco A, Forgione A, Miele L, Vero V, Greco AV, Gasbarrini A, Gasbarrini G. (2005). Fatty liver and drugs. Eur Rev Med Pharmacol Sci. (Review of drugs that can cause steatosis including amiodarone and tamoxifen).
Liu CL, Huang JK, Cheng SP, Chang YC, Lee JJ, Liu TP. (2006). Fatty liver and transaminase changes with adjuvant tamoxifen therapy. Anticancer Drugs. (Ultrasound evidence of fatty liver developed in 53% of 156 Taiwanese women with breast cancer treated with tamoxifen vs 13% of 62 who received chemotherapy alone; rate increased over time, reversing slowly with stopping tamoxifen, but 21% of cases still had steatosis 48 months afterwards).
Ahmed MH, Osman KA, Osman MM. (2006). Invasive and non-invasive investigations for tamoxifen-induced non-alcoholic steatohepatitis (NASH): the benefit of computed tomography scan guided liver biopsy. Pathology. (Letter discussing the role of liver biopsy in making the diagnosis of steatohepatitis in patients on tamoxifen and the focal distribution of fat in the liver shown by CT scan).
Ahmed MH, Osman KA. (2006). Tamoxifen induced-non-alcoholic steatohepatitis(NASH): has the time come for the oncologist to be diabetologist. Breast Cancer Res Treat. (Letter discussing the pathogenesis of steatohepatitis stressing the need to monitor liver tests, lipids and fasting glucose levels in patients on tamoxifen).
Bilici A, Ozguroglu M, Mihmanli I, Turna H, Adaletli I. (2007). A case-control study of non-alcoholic fatty liver disease in breast cancer. Med Oncol. (Cross sectional ultrasound study of 125 women with breast or ovarian cancer and 40 controls demonstrated high rate of steatosis [63-77%, 48% in controls], with highest rates in women on tamoxifen [71%]).
Takamura T, Shimizu A, Komura T, Ando H, Zen Y, Minato H, Matsushita E, et al. (2007). Selective estrogen receptor modulator raloxifene-associated aggravation of nonalcoholic steatohepatitis. Intern Med. (53 year old woman with mild fatty liver disease developed worsening liver enzymes after starting raloxifene for osteoporosis, which improved upon stopping, with ALT rising from 179 to 356 and falling to 118 U/L 3 months after stopping).
Osman KA, Osman MM, Ahmed MH. (2007). Tamoxifen-induced non-alcoholic steatohepatitis: where are we now and where are we going?. Expert Opin Drug Saf. (Opinion article recommending monitoring of liver enzymes during tamoxifen therapy [particularly in overweight and obese patients] and intervening if ALT levels rise to 1.5 times ULN, with therapy directed at altering risk factors for fatty liver disease).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, no cases were attributed to tamoxifen).
Ashraf M, Biswas J, Majumdar S, Nayak S, Alam N, Mukherjee KK, Gupta S. (2009). Tamoxifen use in Indian women--adverse effects revisited. Asian Pac J Cancer Prev. (Among 3000 Indian women with breast cancer treated with tamoxifen, 55% developed fatty liver, which usually resolved upon stopping; no clinical features given).
Saphner T, Triest-Robertson S, Li H, Holzman P. (2009). The association of nonalcoholic steatohepatitis and tamoxifen in patients with breast cancer. Cancer. (Among 1100 women and 5 men with breast cancer in a tumor registry, 24 [2.2%] also had the diagnosis of nonalcoholic steatohepatitis [NASH], 17 of whom developed it after the diagnosis of breast cancer, including 2% of those who received tamoxifen and 0.3% of those who did not; ALT elevations improved slowly upon stopping, mean time to normalization being 23 months, occurring in 14 of 16 subjects).
Rabaglio M, Ruepp B, Soft/Text/Perche Steering Committee. (2010). Death due to liver failure during endocrine therapy for premenopausal breast cancer. Acta Oncol. (Among 4500 women enrolled in trials of tamoxifen versus exemestane and ovarian function suppression, 2 developed acute liver failure, one on exemestane and one tamoxifen; 36 year old on tamoxifen for 10 months was found to have hepatomegaly and fatty liver and died suddenly one month later, autopsy showing cirrhosis and steatosis; few details of liver tests provided).
Cruz MJ, Alves S, Baudrier T, Azevedo F. (2010). Porphyria cutanea tarda induced by tamoxifen. Dermatol Online J. (53 year old woman developed symptoms of porphyria cutanea tarda a year after starting tamoxifen for breast cancer and at 3 years evaluation showed ALT 70 U/L, GGT 130 U/L, but without iron overload, hepatitis C or alcohol abuse; symptoms, porphyrin levels and liver tests abnormalities resolved within 6 months of switching to letrozole).
Ahbeddou N, Belbaraka R, Fetohi M, Errihani H. (2011). Tamoxifen-induced hepatotoxicity. Indian J Cancer. (46 year old woman developed jaundice 4 weeks after starting tamoxifen [laboratory values not given], resolving within 6 weeks of stopping).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to tamoxifen).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attribute to tamoxifen).
Amacher DE, Chalasani N. (2014). Drug-induced hepatic steatosis. Semin Liver Dis. (Review of the medications that can cause hepatic steatosis and steatohepatitis including amiodarone, tamoxifen, lomitapide, mipomersen, and antiretroviral and chemotherapy agents).
Lin Y, Liu J, Zhang X, Li L, Hu R, Liu J, Deng Y, et al. (2014). A prospective, randomized study on hepatotoxicity of anastrozole compared with tamoxifen in women with breast cancer. Cancer Sci. (Among 353 Chinese postmenopausal women with early stage breast cancer [ER+] treated with tamoxifen or anastrozole, the 3 year cumulative rate of fatty liver was higher with tamoxifen [41% vs 15%] although rates of abnormal liver tests were not [24.6% vs 24.7%])).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 were attributed to antineoplastic agents, including 4 due to tamoxifen).
Rabinowich L, Shibolet O. (2015). Drug induced steatohepatitis: An uncommon culprit of a common disease. Biomed Res Int. (Review of the pathogenesis of fatty liver caused by medications mentions that tamoxifen appears to enhance fatty acid synthesis and decrease in triglyceride secretion).
Hsu A, Belkin E, Han S, Pellish R. (2015). Tamoxifen-associated portal vein thrombosis causing severe oesophageal variceal bleeding. BMJ Case Rep. (46 year old woman on long term tamoxifen for breast cancer developed portal vein thrombosis and esophageal variceal bleeding with normal liver tests and imaging demonstrating portal vein thrombosis, responding to variceal banding, nadolol for portal hypertension and stopping tamoxifen, eventually without further bleeding and treatment with aromatase inhibitors).
Satapathy SK, Kuwajima V, Nadelson J, Atiq O, Sanyal AJ. (2015). Drug-induced fatty liver disease: An overview of pathogenesis and management. Ann Hepatol. (Review of drugs that cause fatty liver disease and pathogenesis of fat accumulation and steatohepatitis).
Yang YJ, Kim KM, An JH, Lee DB, Shim JH, Lim YS, Lee HC, et al. (2016). Clinical significance of fatty liver disease induced by tamoxifen and toremifene in breast cancer patients. Breast. (Among 1061 women with breast cancer and normal baseline ALT levels seen over a 1 year period in an Asian medical center, ALT elevations occurred in 45 of 618 [7.7%: peak values 46-237 U/L] who received SERMs vs 22 of 406 [4.5%] who did not; furthermore, fatty liver by imaging tests was found in 47 of 122 [42%] on SERM therapy vs 19 of 95 [20%] controls; nevertheless, no patient developed cirrhosis or died of liver disease).
Wadood A, Chesner R, Mirza M, Zaman S. (2016). Tamoxifen precipitation of familial hypertriglyceridaemia: a rare cause of acute pancreatitis. BMJ Case Rep. (36 year old woman with familial hypertriglyceridemia and ER+ breast cancer developed recurrent episodes of pancreatitis associated with high serum levels of triglycerides that stopped once tamoxifen was discontinued).
Yan M, Wang J, Xuan Q, Dong T, He J, Zhang Q. (2017). The relationship between tamoxifen-associated nonalcoholic fatty liver disease and the prognosis of patients with early-stage breast cancer. Clin Breast Cancer. (Among 646 patients with early stage breast cancer treated with tamoxifen, 221 developed fatty liver and had a slightly lower disease free survival [but not overall survival] and predictive factors for fatty liver included body mass index, triglyceride levels, LDL cholesterol levels and ALT levels after 6 months of therapy).
Miele L, Liguori A, Marrone G, Biolato M, Araneo C, Vaccaro FG, Gasbarrini A, et al. (2017). Fatty liver and drugs: the two sides of the same coin. Eur Rev Med Pharmacol Sci. (Review of the pathogenesis of fatty liver and steatohepatitis caused by medications including amiodarone, tamoxifen, methotrexate, valproate and antiretroviral and chemotherapy agents).
Hong N, Yoon HG, Seo DH, Park S, Kim SI, Sohn JH, Rhee Y. (2017). Different patterns in the risk of newly developed fatty liver and lipid changes with tamoxifen versus aromatase inhibitors in postmenopausal women with early breast cancer: A propensity score-matched cohort study. Eur J Cancer. (In a retrospective cohort study of 328 Korean women with breast cancer receiving antiestrogen adjuvant therapy, fatty liver as detected by ultrasound arose in 13 per 100 patient years on tamoxifen versus 8 per 100 on aromatase inhibitors [anastrozole or letrozole], and those on tamoxifen were more likely to progress [42% vs 10%]).
Chang HT, Pan HJ, Lee CH. (2018). Prevention of tamoxifen-related nonalcoholic fatty liver disease in breast cancer patients. Clin Breast Cancer. (In a retrospective analysis of 266 women with early breast cancer treated with tamoxifen, 123 had fatty liver and risk factors for its development or worsening were baseline BMI and whether the patient engaged in regular physical activity, suggesting that exercise might be an effective means of preventing development of fatty liver in women on tamoxifen).
Wyffels K, Horsmans Y. (2019). Tamoxifen-induced hepatotoxicity caused by drug interaction with direct-acting antiviral agents for hepatitis C. J Oncol Pharm Pract. (68 year old man with hemophilia B and chronic hepatitis C had a sudden rise in serum enzymes [bilirubin 2.0 mg/dL, ALT 548 U/L, Alk P 76 U/L] 7 weeks after starting direct antiviral therapy [Viekira Pak], which resolved with stopping tamoxifen that he had been taking for breast cancer in remission, suggesting that drug-drug interactions with tamoxifen may cause serious adverse events; he was later able to tolerate tamoxifen after clearance of HCV).
Meunier L, Larrey D. Chemotherapy-associated steatohepatitis. Ann Hepatol 2020: S1665-2681(20)30004-1. (Review of the chemotherapeutic agents that have been linked to fatty liver and steatohepatitis including 5-fluorouracil, irinotecan, methotrexate, tamoxifen, corticosteroids and asparaginase many of which cause fat accumulation because of mitochondrial injury, which arises with prolonged therapy, can become chronic, but usually reverses once the agent is stopped).
Hong J, Huang J, Shen L, Zhu S, Gao W, Wu J, Huang O, et al. (2020). A prospective, randomized study of Toremifene vs. tamoxifen for the treatment of premenopausal breast cancer: safety and genital symptom analysis. BMC Cancer. (Among 92 women with early breast cancer treated with tamoxifen vs toremifene for one year, fatty liver arose in a similar proportion: 32% vs 27%]).
Yoo JJ, Lim YS, Kim MS, Lee B, Kim BY, Kim Z, Lee JE, et al. (2020). Risk of fatty liver after long-term use of tamoxifen in patients with breast cancer. PLoS One. (Among 900 women with breast cancer treated between 2007 and 2017 with tamoxifen, an aromatase inhibitor or no therapy for a median of 49 months, de novo development of fatty liver was more frequent with tamoxifen as was worsening of underlying fatty liver, but neither seemed to affect overall survival).

## OTHER REFERENCE LINKS

1 Recent References on Tamoxifen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=tamoxifen+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tamoxifen: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=tamoxifen)